# Stiripentol

## OVERVIEW

### Introduction

Stiripentol is a structurally unique anticonvulsant that has been introduced as adjuvant therapy of Dravet syndrome, a rare form of severe childhood epilepsy. There is limited information on the safety of stiripentol, but it has not been associated with serum aminotransferase elevations or linked to cases of clinically apparent liver injury.

### Background

Stiripentol (stir" i pen' tol) is an aromatic alcohol, structurally unrelated to other anticonvulsants that is approved for use in the United States as adjunctive therapy of seizures in patients with Dravet syndrome, a rare childhood-onset disorder marked initially by hemiclonic seizures, often triggered by fever and frequently prolonged. Myoclonic, atypical absence, focal dyscognitive and tonic seizures develop over time, and children often suffer from developmental delay and have an increased risk for sudden death during severe seizures or status epilepticus. Seizures are often refractory and problematic, usually worsening with sodium channel agents such as carbamazepine, phenytoin and lamotrigine and typically improving with clobamate and stiripentol. The anticonvulsant activity of stiripentol appears to be mediated by its ability to enhance gamma-aminobutyric acid (GABA) mediated inhibition of synaptic transmission via binding to the GABA-A receptor at a site distinct from that benzodiazepines. Stiripentol may also act by inhibition of lactic dehydrogenase, an enzyme that catalyzes the interconversion of pyruvate to lactate which results in an increase in pyruvate and ATP which secondarily affects potassium channels on neuronal cell membranes. Stiripentol was approved for use in the United States in 2018 as an anticonvulsant to be used in combination with clobazam as therapy of Dravet syndrome. Stiripentol is available in capsules of 250 and 500 mg and as a powder in 250 and 500 mg amounts for oral suspension under the brand name Diacomit. The recommended dose is 50 mg/kg daily administered in 2 or 3 divided doses. Changes in dose and discontinuations should be done gradually. Side effects are common and can include somnolence, anorexia, nausea, agitation, ataxia, hypotonia, tremor, dysarthria and insomnia. Rare, but potential severe adverse events include severe somnolence, marked weight loss, neutropenia and thrombocytopenia, and suicidal ideation and behavior.

### Hepatotoxicity

Limited data are available on the safety of stiripentol, based mainly on open-label and small, placebo controlled clinical trials in children with Dravet syndrome. In these studies, addition of stiripentol to chronic clobazam therapy was not associated with an increased frequency of serum aminotransferase elevations, and there were no instances of clinically apparent liver injury. Long term therapy with stiripentol has been linked to low rates of ALT and alkaline phosphatase elevations but with increases in gamma glutamyl transpeptidase (GGT) in up to 38% of cases. Since its general availability, there have been no published case reports of stiripentol hepatotoxicity. Thus, clinically apparent liver injury due to stiripentol must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which stiripentol might cause liver injury is not known. Stiripentol is extensively metabolized by the liver via the microsomal P450 system, and it is a moderate inhibitor of CYP 2C 19 and, to a lesser extent, CYP 3A4 and 1A2. Stiripentol has major drug-drug interactions and can alter metabolism of many other anticonvulsants including clobazam which is commonly used in combination with stiripentol. Because clobazam is converted to its active metabolite by CYP 2C19 and 3A4, inhibition of the enzyme activity by stiripentol increases clobazam levels and can lead to toxicity for which reason the dose of clobazam should be reduced by half when stiripentol is added.

### Outcome and Management

There is no reason to suspect cross sensitivity to hepatotoxicity of stiripentol with other drugs for epilepsy such as the benzodiazepines or aromatic anticonvulsants.

Drug Class: Anticonvulsants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Stiripentol – Diacomit®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Stiripentol | 49763-96-4 | C14-H18-O3 | Stiripentol chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 10 April 2019

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999; stiripentol is not discussed).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-42. (Review of anticonvulsant induced liver injury; stiripentol is not discussed).
Smith MD, Metcalf CS, Wilcox KS. Pharmacotherapy of the epilepsies. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 303-26. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that in safety analysis in several hundred treated cases there was no increase in ALT values or discontinuations for liver test abnormalities and no instances of clinically apparent liver injury).
Stiripentol: efficacy and tolerability in children with epilepsy. Epilepsia 1999; 40: 1618-26. (Among 212 French children with various forms of epilepsy treated with stiripentol, 48% had troublesome adverse events, most commonly neurobehavioral [30%] or gastrointestinal [29%], but only 1 child had to discontinue therapy because of adverse events; no mention of ALT elevations or hepatotoxicity). 10565591
Chiron C, Marchand MC, Tran A, Rey E, d'Athis P, Vincent J, Dulac O, et al. Stiripentol in severe myoclonic epilepsy in infancy: a randomized placebo-controlled syndrome-dedicated trial. STICLO study group. Lancet 2000; 356 (9242): 1638-42. (Among 41 children with severe myoclonic epilepsy receiving valproate and clobazam to which was added stiripentol or placebo for 2 months, clinical response rates were higher in those on stiripentol [71% vs 5%] as were adverse event rates [100% vs 40%], most responding to dose reduction and none attributed to liver injury). 11089822
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to anticonvulsants). 23419359
Wirrell EC, Laux L, Franz DN, Sullivan J, Saneto RP, Morse RP, Devinsky O, et al. Stiripentol in Dravet syndrome: results of a retrospective U.S. study. Epilepsia 2013; 54: 1595-604. (Survey of 13 US clinicians managing 82 children with Dravet syndrome identified adverse events in 46%, which were neurobehavioral in 27% and gastrointestinal in 10%; no mention of ALT elevations or hepatotoxicity). 23848835
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were attributed to anticonvulsants, but none to clobazam or other benzodiazepine anticonvulsants). 25754159
Inoue Y, Ohtsuka Y; STP-1 Study Group. Long-term safety and efficacy of stiripentol for the treatment of Dravet syndrome: A multicenter, open-label study in Japan. Epilepsy Res 2015; 113: 90-7. (Among 24 Japanese children started on stiripentol of whom 19 were continued for up to 40 weeks, adverse events were frequent [91%], the common events being somnolence [79%], anorexia [67%], ataxia [58%], mild ALT elevations [17%], mild Alk P [8%] and mild-to-moderate GGT [38%], but no adverse event led to drug discontinuation). 25986195
Nickels KC, Wirrell EC. Stiripentol in the management of epilepsy. CNS Drugs 2017; 31: 405-16. (Review of the structure, mechanism of action, pharmacology, clinical efficacy, current uses and safety of stiripentol; mentions that adverse events can be caused by its effects on drug levels of other anticonvulsants and major problematic side effects are neurobehavioral and gastrointestinal; no mention of ALT elevations or hepatotoxicity). 28434133
Drugs for epilepsy. Med Lett Drugs Ther 2017; 59 (1526):121-30. (Concise review of the currently available drugs for epilepsy does not discuss stiripentol). 28746301
Myers KA, Lightfoot P, Patil SG, Cross JH, Scheffer IE. Stiripentol efficacy and safety in Dravet syndrome: a 12-year observational study. Dev Med Child Neurol 2018; 60: 574-8. (Among 41 children with Dravet syndrome followed at 2 epilepsy centers [in UK and Australia] who were treated with stiripentol for up to 12 years, 73% reported stiripentol related adverse events, most commonly anorexia, weight loss, sedation and behavioral changes and one case of protein-losing enteropathy and one of recurrent pancreatitis; ALT elevations and hepatotoxicity were not mentioned). 29473155
Uchida Y, Terada K, Madokoro Y, Fujioka T, Mizuno M, Toyoda T, Kato D, et al. Stiripentol for the treatment of super-refractory status epilepticus with cross-sensitivity. Acta Neurol Scand 2018; 137: 432-7. (Among 5 adults with refractory status epilecticus and hypersensitivity reactions to various anticonvulsants [erythema multiforme, drug rash with eosinophilia and systemic symptoms, or toxic epidermal necrolysis; 3 with hepatitis], adding stiripentol led to control of seizures without recurrence of allergic reactions). 29313881
Yıldız EP, Ozkan MU, Uzunhan TA, Bektaş G, Tatlı B, Aydınlı N, Çalışkan M, et al. Efficacy of stiripentol and the clinical outcome in Dravet syndrome. J Child Neurol 2019; 34: 33-7. (Among 21 Japanese children with Dravet syndrome, 86% were taking stiripentol, of whom 8 had adverse events, most commonly sedation [n=6] or ataxia [n=5], and “no patient had laboratory abnormalities in liver” function tests). 30362398

## OTHER REFERENCE LINKS

1. Recent References on Stiripentol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(tiagabine+AND+Nipecotic+Acids/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Stiripentol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=tiagabine)